# Doxylamine

## OVERVIEW

### Introduction

Doxylamine is a first generation antihistamine that is used for symptoms of allergic rhinitis and the common cold and as a short acting sedative. Doxylamine has not been linked to instances of clinically apparent acute liver injury.

### Background

Doxylamine (dox il' a meen) is a first generation antihistamine that is used to treat the symptoms of allergic rhinitis and the common cold, including sneezing, cough, runny note, watery eyes and itching. Because of its sedating side effects, it is also used as a mild sleeping aid and sedative. Doxylamine belongs to the ethanolamine class of antihistamines (with clemastine and dimenhydrinate) and was approved for use in the United States in 1948. It is still widely used today, largely in combination with other agents such as dextromethorphan, pseudoephedrine, aspirin and acetaminophen in over-the-counter products for relief of symptoms of the common cold and allergic rhinitis. Representative brand names of products that include doxylamine include Alka-Seltzer Plus, Night Time Cold/Flu Relief, NyQuil, and Sleep Aid. The recommended adult oral dose is 25 to 50 mg. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Despite widespread use over many decades, doxylamine has not been linked to liver test abnormalities or to clinically apparent liver injury. The reason for its safety may relate its short half-life and limited duration of use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Doxylamine – Generic, Sleep Aid®, Unisom®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Doxylamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Doxylamine | 469-21-6 | C17-H22-N2-O | Doxylamine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Doxylamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Doxylamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Doxylamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Doxylamine)